# Valsartan

## OVERVIEW

### Introduction

Valsartan is an angiotensin II receptor blocker used alone or in combination with other agents to treat hypertension and reduce cardiovascular mortality after myocardial infarction. Valsartan is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Valsartan (val sar' tan) was the second angiotensin II receptor blocker (ARB) to be approved for use in the United States and is widely used for therapy of hypertension. Valsartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II which accounts for its antihypertensive activity. Valsartan was approved for use in the United States for hypertension in 1996 and indications were subsequently broaded to the treatment of heart failure and for reduction in cardiovascular mortality in patients with left ventricular dysfunction after myocardial infarction. Valsartan is available in 40, 80, 160 and 320 mg tablets generically and under the trade name Diovan. The typical initial dose of valsartan in adults in 80 to 160 mg once daily, and it is used long term. Valsartan is also available in fixed combinations with hydrochlorothiazide (Diovan-HCT), amlodipine (Exforge and Exforge HCT) and aliskiren (Valturna). Side effects of valsartan are uncommon, but can include headache, dizziness, fatigue, cough, gastrointestinal upset, and fetal toxicity. In addition, many ARBs including valsartan have been linked to cases of severe sprue-like enteropathy. The enteropathy arises after months or years of therapy and presents with severe diarrhea, weight loss, abdominal discomfort and fatigue. Intestinal biopsy shows villous flattening and atrophy similar to celiac disease. However, the enteropathy does not improve with a gluten-free diet but does resolve with stopping the angiotensin receptor blocker.

### Hepatotoxicity

Valsartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in association with valsartan therapy. The onset is usually within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but valsartan therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. In addition, serum aminotransferase elevations can accompany the enteropathy associated with ARB therapy, probably as a result of fatty liver disease and steatohepatitis due to the diarrhea and malnutrition.

Likelihood score: D (Possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury that has been associated with valsartan is not known, but it resembles idiosyncratic liver injury due to a hypersensitivity reaction. Valsartan does not appear to be metabolized by the cytochrome P450 system to a major degree.

### Outcome and Management

The instances of acute liver injury reported with valsartan use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with valsartan induced acute liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of valsartan are given in the Overview section on the Angiotensin II Receptor Antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Eprosartan, Irbesartan, Losartan, Olmesartan, Telmisartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Valsartan – Diovan®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Valsartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Valsartan | 137862-53-4 | C24-H29-N5-O3 | Chemical Structure for Valsartan

## OTHER REFERENCE LINKS

1. Recent References on Valsartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Valsartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Valsartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Valsartan)